# Thiabendazole

## OVERVIEW

### Introduction

Thiabendazole is a broad spectrum anthelmintic agent used predominantly in treatment of intestinal pinworm and strongyloides infection, which recently has been replaced by better tolerated agents. Thiabendazole therapy has been shown to cause clinically apparent cholestatic liver injury which is rare, but can be severe.

### Background

Thiabendazole (thye" a ben' da zole) is a benzimidazole anthelmintic agent similar in structure and mechanism of action to albendazole and mebendazole. The benzimidazoles act by selective binding to beta-tubulin of parasitic worms, causing their immobilization and death. Thiabendazole was approved in the United States in 1967 but has subsequently been withdrawn because of the availability of other, better tolerated anthelmintic agents, such as ivermectin, albendazole, and mebendazole. Thiabendazole is, however, still available in other countries and is used in veterinary medicine in the United States. Thiabendazole is also used as a food preservative and fungicide and trace amounts can be detected in some fruit juices and animal products. Its major medical indication is strongyloidiasis infestation. Thiabendazole was formerly available in chewable tablets of 500 mg under the trade name of Mintezol and as an oral suspension. The typical dose in adults was 1500 mg orally daily for 1 to 3 days. The dose in children is based upon body weight. Thiabendazole therapy is associated with frequent minor but troublesome side effects including dizziness, nausea, diarrhea, gastrointestinal upset, headaches and hair loss. Severe adverse events can include liver disease, keratoconjunctivity sicca, photosensitivity, skin rash and hypersensitivity reactions.

### Hepatotoxicity

Thiabendazole therapy is associated with serum aminotransferase elevations in up to 36% of patients, but it is usually given for a brief period only and its effects on serum enzyme levels after single dose administration has not been systematically evaluated. Importantly, thiabendazole therapy has also been associated with clinically apparent liver injury which can be prolonged and severe. The onset of injury is usually within 1 to 2 weeks of finishing a 1 to 5 day course of therapy. The pattern of serum enzyme elevations is typically cholestatic. Autoantibodies are usually negative and fever, arthralgias and rash are uncommon. Several reported cases have been associated with sicca complex marked by parotid enlargement and tenderness, dry eyes and dry mouth arising before the onset of jaundice (Case 1). The cholestatic injury can be associated with damage to small bile ducts and with prolonged jaundice and/or pruritus and alkaline phosphatase elevations. Several instances of prolonged cholestasis and chronic vanishing bile duct syndrome and end stage liver disease has been reported even after a single dose of thiabendazole.

Likelihood score: B (highly likely cause of clinically apparent liver injury)

### Mechanism of Injury

Thiabendazole hepatotoxicity appears to be due to an immunological reaction to the drug, which is directed largely at bile, lacrimal, and salivary gland ducts.

### Outcome and Management

While most reported cases of thiabendazole induced liver injury were self-limited, many were marked by severe and prolonged cholestasis. Several cases of prolonged jaundice with vanishing bile duct syndrome and evolution to cirrhosis leading to liver transplantation have been reported. Patients with acute liver injury attributed to thiabendazole should avoid repeat exposure. It is unknown whether there is cross sensitivity with other benzimidazoles (such as albendazole and mebendazole), but there probably is and switching to another class of anthelmintic agents is appropriate if therapy is still needed.

Drug Class: Anthelmintic Agents

## CASE REPORT

### Case 1. Cholestatic hepatitis followed by chronic cholestatic syndrome and cirrhosis after a short course of thiabendazole.(1)

A 46 year old woman with suspected trichinosis was treated with thiabendazole (25 mg/kg twice daily for 5 days) and prednisone (40 mg/day). Two weeks later, she noted dryness of the eyes and mouth with low grade fever. Shortly thereafter she developed dark urine and pruritus. She had no history of liver disease or drug allergies and drank little alcohol. On admission, she had prominence of the parotid glands and right upper quadrant tenderness without enlargement of the liver or spleen. She was jaundiced but had no other signs of chronic liver disease. Laboratory values showed a total bilirubin of 16.4 mg/dL with a direct of 11.5 mg/dL (Table). Serum aminotransferase levels were 3 to 20 fold elevated and 5’ nucleotidase was 5 times elevated. Tests for hepatitis A and B and routine autoantibodies were normal. Ultrasound and CT scans of the abdomen showed no abnormalities and endoscopic retrograde cholangiopancreatography revealed no evidence of biliary obstruction. A liver biopsy showed marked intrahepatic cholestasis and a relative paucity of bile ducts. A salivary gland biopsy showed sialadenitis with prominent destruction of acini and ductules. She remained deeply jaundiced, but reevaluation showed no evidence for other liver disease. Over the next 8 months her symptoms of dry mouth and eyes improved, but she continued to have pruritus and mild jaundice. Two and a half years after exposure to thiabendazole she developed ascites and variceal bleeding. A repeat liver biopsy showed a micronodular cirrhosis with little inflammation and no steatosis. She remained negative for antinuclear (ANA), antimitochondrial (AMA), and antimicrosomal antibodies. Shortly thereafter, she underwent liver transplantation; the explant again showed micronodular cirrhosis.

#### Key Points

Medication: | Thiabendazole (25 mg/kg twice daily for 5 days)
Pattern: | Cholestatic pattern (R=~0.8)
Severity: | 5+ (ultimately leading to cirrhosis and liver transplantation)
Latency: | 2 weeks
Recovery: | Incomplete
Other medications: | Prednisone 40 mg daily for short period

#### Laboratory Values

Time After Starting | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Normal | Normal | Normal | Trichinosis
3 weeks | 142 | N/A | 16.4 | Admission
6 weeks | | | 28.1 | Liver biopsy
10 weeks | 50 | 248 | 23.5 | AMA and ANA negative
1 year | 108 | 584 | 2.2 | Sicca syndrome resolved
2.5 years | 98 | 487 | 2.6 | Variceal hemorrhage
Normal Values | <40 | <98 | <1.2

#### Comment

Thiabendazole typically causes an acute cholestatic hepatitis, but in half of cases the cholestatic hepatitis has been preceded by onset of a sicca syndrome with dry eyes and dry mouth and parotid enlargement, with salivary gland biopsies showing inflammation and damage to acini and ductules. The cholestatic hepatitis may also be characterized by damage to bile ducts and result in a prolonged jaundice or cholestasis, with persistence of liver test abnormalities for months or years. In its most severe form, this prolonged cholestasis is also marked by vanishing bile duct syndrome and chronic cholestasis that can result in cirrhosis, portal hypertension and end stage liver disease. The condition resembles primary biliary cirrhosis, but typically presents in an acute fashion with jaundice and symptoms, whereas primary biliary cirrhosis usually presents insidiously with liver test abnormalities and pruritus long before onset of jaundice. Interestingly, primary biliary cirrhosis can also be associated with keratoconjunctivitis sicca, and the histology of the involved salivary and lacrimal glands resembles that of primary biliary cirrhosis with intense inflammation and damage to small bile ducts, with rupture and granulomatous inflammation in the acute phase. This striking syndrome, several cases of which have been reported after short courses of thiabendazole, has not been reported with the other anthelmintic benzimidazoles, mebendazole and albendazole.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Thiabendazole – Generic, Mintezol®

DRUG CLASS

Anthelmintic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=thiabendazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Thiabendazole | 148-79-8 | C10-H7-N3-S

## CITED REFERENCE

1 Roy MA, Nugent FW, Aretz HT. Micronodular cirrhosis after thiabendazole. Dig Dis Sci 1989; 34: 938-41.2721325

## ANNOTATED BIBLIOGRAPHY

References updated: 20 April 2026

Zimmerman HJ. Anthelminthics. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 626-8. (Expert review of hepatotoxicity of anthelmintics written in 1999; mentions that thiabendazole has been associated with at least 17 instances of cholestatic jaundice).
Keiser J, McCarthy J, Hotez P. Chemotherapy of helminth infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1001-9. (Textbook of pharmacology and therapeutics; albendazole and mebendazole are discussed but not thiabendazole).
Hennekeuser HH, Pabst K, Poeplau W, Gerok W. Thiabendazole for the treatment of trichinosis in humans. Tex Rep Biol Med 1969; 27(Suppl 2): 582-96. (Among 23 patients with trichinosis [during an epidemic in Germany], treated with thiabendazole [50 mg/kg/day] for 10 days, one patient [4%] developed liver injury with ALT and AST elevations and biopsy showing hepatocellular necrosis and cholestasis; no further information given). 5369623
Bayles MAH. Chromomycosis: treatment with thiabendazole. Arch Dermatol 1971; 104: 476-85. (Among 14 patients with chromomycosis treated with thiabendazole [25 mg/kg/day] long term, 5 developed toxic-allergic hepatitis arising after 1-18 months of therapy, 4 with jaundice, 1 died; rapid recurrence on restarting; few details given). 5120175
Jalota R, Freston JW. Severe intrahepatic cholestasis due to thiabendazole. Am J Trop Med Hyg 1974; 23: 676-8. (32 year old woman developed fever and rash a day after finishing 8 day course of thiabendazole for pinworms, with subsequent jaundice [bilirubin rising to 23 mg/dL, AST 123 U/L, Alk P 209 U/L]; liver biopsy showed intrahepatic cholestasis, but she died of hemorrhage, a complication of transhepatic cholangiogram). 4847042
Feregrino Goyos M, Lifshitz Guinzberg A, Hernández Berumen A, Ramírez Degollado J, Cervantes LF. [Intrahepatic cholestasis by thiabendazole treated with phenobarbital]. Prensa Med Mex 1976; 41: 167-71. Spanish. 995842
Fink AI, MacKay CJ, Cutler SS. Sicca complex and cholestatic jaundice in two members of a family caused by thiabendazole. Trans Am Ophthalmol Soc 1978; 76: 108-15. (Mother and daughter developed sicca syndrome followed by jaundice after 5 members of family were given 2 doses of thiabendazole for pinworms; mother, aged 43, developed symptoms at 2 weeks with parotid enlargement, dry mouth and eyes, and jaundice 1 week later [peak bilirubin 15.7 mg/dL, Alk P 944 U/L, AST 200 U/L], resolving in 1 month; child, aged 17, had onset of symptoms in 1 week and jaundice in 2, with prolonged jaundice, pruritus and dry eyes, ultimately resolving). 754367
Fink AI, MacKay CJ, Cutler SS. Sicca complex and cholangiostatic jaundice in two members of a family probably caused by thiabendazole. Ophthalmology 1979; 86: 1892-6. (Same cases as described by the authors in Trans Am Ophthalmol Soc 1978). 553260
Rex D, Lumeng L, Eble J, Rex L. Intrahepatic cholestasis and sicca complex after thiabendazole. Report of a case and review of the literature. Gastroenterology 1983; 85: 718-21. (55 year old man developed jaundice 8 days after starting a 3 day course of thiabendazole for strongyloidiasis [bilirubin 30.6 rising to 40.5 mg/dL, AST 562 U/L, Alk P 820 U/L], and dry eyes, but normal salivary gland biopsy, liver biopsy showing intrahepatic cholestasis without duct loss, prolonged, severe course [confusion and edema], but ultimate recovery). 6873616
Manivel JC, Bloomer JR, Snover DC. Progressive bile duct injury after thiabendazole administration. Gastroenterology 1987; 93: 245-9. (27 year old man developed jaundice 2 weeks after finishing 1 week course of thiabendazole for suspected strongyloidiasis [peak bilirubin 24.5 mg/dL, ALT 328 U/L, Alk P 6280 U/L], liver biopsies showing duct injury and loss, followed by intractable pruritus and liver failure and liver transplant 3 years after onset). 3297909
Davidson RN, Weir WR, Kaye GL, McIntyre N. Intrahepatic cholestasis after thiabendazole. Trans R Soc Trop Med Hyg 1988; 82: 620. (17 year old boy developed dry mouth 1 day after finishing 3 day course of thiabendazole for strongyloides infection, becoming jaundiced 2 weeks later [bilirubin rising to 23.8 mg/dL, ALT 102 U/L, Alk P 350 U/L], biopsy showed severe intrahepatic cholestasis, jaundice resolved in 6 and serum enzyme elevations in 12 months). 3256116
Roy MA, Nugent FW, Aretz HT. Micronodular cirrhosis after thiabendazole. Dig Dis Sci 1989; 34: 938-41. (46 year old woman developed dry eyes and mouth 2 weeks after a 5 day course of thiabendazole for trichinosis, followed by jaundice and pruritus 1 week later [bilirubin 16.4 mg/dL, ALT 487 U/L], liver biopsy showed intrahepatic cholestasis and paucity of bile ducts, with prolonged jaundice and pruritus and variceal hemorrhage 2.5 years later: Case 1). 2721325
Bion E, Pariente EA, Maitre F. Severe cholestasis and sicca syndrome after thiabendazole. J Hepatol 1995; 23: 762-3. (56 year old man developed severe dry mouth and eyes 2 weeks after a 3 day course of thiabendazole, followed 3 days later by jaundice [bilirubin rising to 27.2 mg/dL, ALT 5.5 times ULN, Alk P 8 times ULN, GGT 29 times ULN], liver biopsy showed intrahepatic cholestasis and salivary gland biopsy sialadenitis, slow recovery and persistent GGT elevation 6 years later). 8750181
Skandrani K, Richardet JP, Duvoux C, Cherqui D, Zafrani ES, Dhumeaux D. [Hepatic transplantation for severe ductopenia related to ingestion of thiabendazole]. Gastroenterol Clin Biol 1997; 21: 623-5. French. (26 year old man developed dry eyes and dry mouth 4 days after finishing a second course of thiabendazole [25 mg/kg for 3 days] for strongyloidiasis, with subsequent jaundice [bilirubin 18.3 mg/dL, ALT 2.5 times ULN, Alk P 1.5 times ULN], liver biopsy showed intrahepatic cholestasis and loss of bile ducts; subsequent persistent severe cholestasis evolving into cirrhosis; liver transplant 1.5 years after onset). 9587501
Eland IA, Kerkhof SC, Overbosch D, Wismans PJ, Stricker BH. [Cholestatic hepatitis ascribed to the use of thiabendazole]. Ned Tijdschr Geneeskd 1998; 142: 1331-4. Dutch. (Two women with cholestatic hepatitis arising 2-3 weeks after 2 day course of thiabendazole for strongyloidiasis, with slow and incomplete recovery). 9752041
Drugs for parasitic infections. Treat Guidel Med Lett 2013; 11 (Suppl): e1-31. (Brief description of drugs for parasitic infections in adults and children as well as a table of their major side effects; thiabendazole is mentioned as a drug of choice but is not discussed).
Bisoffi Z, Buonfrate D, Angheben A, Boscolo M, Anselmi M, Marocco S, Monteiro G, et al. Randomized clinical trial on ivermectin versus thiabendazole for the treatment of strongyloidiasis. PLoS Negl Trop Dis 2011; 5: e1254. (Controlled trial of thiabendazole [2 daily doses for 2 days] vs ivermectin [single dose] in 198 patients with Strongyloidiasis found similar efficacy, but fewer side effects with ivermectin; no mention of hepatotoxicity or ALT elevations). 21814588
Groh M, Blanche P, Calmus Y, Guillevin L. Thiabendazole-induced acute liver failure requiring transplantation and subsequent diagnosis of polyarteritis nodosa. Clin Exp Rheumatol. 2012; 30(1 Suppl 70): S107-9. (33 year old man with chronic hypereosinophilia developed severe liver injury after experimental therapy with thiabendazole which resulted in vanishing bile duct syndrome, hepatic failure and liver transplantation; few details given). 22640653
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, only one of which was attributed to an anthelmintic, mebendazole; none were attributed to thiabendazole). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 409 [46%] were attributed to antimicrobial agents, but none to anthelmintics or to thiabendazole). 25754159
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 5 [1%] were attributed to albendazole, 1 to mebendazole, 1 to thiabendazole, but none to fenbendazole). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Thiabendazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Thiabendazole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Thiabendazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Thiabendazole)